# Glasdegib

## OVERVIEW

### Introduction

Glasdegib is an orally available small molecule inhibitor of the signaling molecule hedgehog which is used as an antineoplastic agent in the treatment of acute myeloid leukemia. Glasdegib is associated with a moderate rate of serum aminotransferase elevations during therapy and is suspected to cause rare instances of clinically apparent acute liver injury.

### Background

Glasdegib (glas deg' ib) is a potent small molecule inhibitor of hedgehog, a signaling molecule that is frequently overexpressed in cancer cells including leukemia stem cells in patients with acute myeloid leukemia (AML). The hedgehog intracellular signaling cascade promotes cell growth and proliferation. Mutations in hedgehog are found in many types of cancer cells and can lead to unregulated cell growth. Glasdegib in combination with cytarabine with or without daunorubicin has been found to induce disease remissions and prolong overall survival in patients with AML and high-risk myelodysplastic syndromes who are unsuitable for conventional chemotherapy regimens. Glasdegib received accelerated approval for this indication in the United States in 2018 and is available in tablets of 40 mg under the brand name Daurismo. The recommended dose is 120 mg once daily, continued until progressive disease or intolerable toxicity occurs. Side effects are common and can include fatigue, myalgia, arthralgia, fever, diarrhea, nausea, abdominal pain, dizziness, headache, hypotension, cough and stomatitis. Uncommon, but potentially severe side effects include posterior reversible encephalopathy syndrome, febrile neutropenia and sepsis, QTc prolongation, pancreatitis and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum ALT levels are common during glasdegib therapy, occurring in 31% of patients and rising above 5 times the upper limit of the normal range in 11%. Glasdegib has had limited clinical use but has not been linked to instances of acute liver injury with symptoms or jaundice. Because of the limited clinical experience with the use of hedgehog inhibitors, their potential for causing liver injury is not well defined.

Likelihood score: E* (unproved but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of the liver injury due to glasdegib is not known. Glasdegib is metabolized in the liver largely by the cytochrome P450 system (largely CYP 3A4) and is susceptible to drug-drug interactions with inhibitors or inducers of the microsomal enzyme system.

### Outcome and Management

Glasdegib therapy has been associated with transient serum aminotransferase elevations during therapy, but has not been linked to instances of acute liver injury with jaundice or symptoms. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks or if symptoms or jaundice arise.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Glasdegib – Daurismo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Glasdegib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Glasdegib | 1095173-27-5 | C21-H22-N6-O | Glasdegib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 January 2019

Abbreviation: AML, acute myelogenous leukemia.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 before the availability of glasdegib and other hedgehog inhibitors).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions glasdegib- and comparator-treatment had similar rates of elevations in ALT [31% vs 28%], AST [36% vs 30%] and alkaline phosphatase [29% vs 30%], and no patient developed clinically apparent liver injury).
Savona MR, Pollyea DA, Stock W, Oehler VG, Schroeder MA, Lancet J, McCloskey J, et al. Phase Ib study of glasdegib, a hedgehog pathway inhibitor, in combination with standard chemotherapy in patients with AML or high-risk MDS. Clin Cancer Res 2018; 24: 2294-303. (Among 52 patients with AML or myelodysplastic syndromes treated with glasdegib [100 or 200 mg daily] combined with cytarabine or decitabine alone or cytarabine and daunorubicin, complete responses occurred in 16 [31%] and adverse event rates were common but considered manageable; no mention of ALT elevations or hepatotoxicity). 29463550
Cortes JE, Douglas Smith B, Wang ES, Merchant A, Oehler VG, Arellano M, DeAngelo DJ, et al. Glasdegib in combination with cytarabine and daunorubicin in patients with AML or high-risk MDS: Phase 2 study results. Am J Hematol 2018; 93: 1301-10. (Among 69 patients with AML or myelodysplastic syndromes treated with glasdegib orally once daily with intravenous cytarabine and daunorubicin in six 28-day cycles, 47% had a complete remission, but all had adverse events that were often severe, including febrile neutropenia [64%], anemia [41%] and ALT elevations [30%], some being above 5 times ULN [5.7%]). 30074259
Cortes JE, Heidel FH, Hellmann A, Fiedler W, Smith BD, Robak T, Montesinos P, et al. Randomized comparison of low dose cytarabine with or without glasdegib in patients with newly diagnosed acute myeloid leukemia or high-risk myelodysplastic syndrome. Leukemia 2019; 33: 379-89. (Among 132 patients with AML or high-risk myelodysplastic syndromes who were treated with intravenous cytarabine with or without oral glasdegib, median overall survival was greater with the combination [8.8 vs 4.9 months] while adverse events rates were similar, serious adverse events occurring in 78% vs 79% of patients and liver test abnormalities in 11% vs 10% all of which were transient, without symptoms or jaundice and not necessitating drug discontinuation). 30555165
Hoy SM. Glasdegib: first global approval. Drugs 2019; 79: 207-13. (Review of the mechanism of action, history of development, pharmacology, efficacy and safety of glasdegib shortly after its initial approval as therapy of AML; mentions that liver enzyme elevations were frequent during glasdegib therapy, and they were not associated with jaundice or symptoms and did not require early drug discontinuation). 30666593

## OTHER REFERENCE LINKS

1. Recent References on Glasdegib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Glasdegib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Glasdegib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Glasdegib)